# Fluphenazine

## OVERVIEW

### Introduction

Fluphenazine is a phenothiazine and antipsychotic agent which is no longer in common use. Fluphenazine can cause mild and transient serum enzyme elevations and has been linked to rare instances of clinically apparent cholestatic liver injury.

### Background

Fluphenazine (floo fen' a zeen) is a tricyclic aliphatic phenothiazine which acts by postsynaptic inhibition of dopamine receptors. Fluphenazine has other peripheral and central nervous system effects, producing both alpha adrenergic stimulation and blocking histamine- and serotonin-mediated effects. Fluphenazine was approved in the United States in 1972 for use in the therapy of acute and chronic psychosis. It was formerly a commonly prescribed antipsychotic medication, but in recent years has been replaced in large part by the atypical antipsychotics, which have fewer extrapyramidal side effects. Fluphenazine is currently used as parentral therapy of psychosis and is available generically in solution for depot injection. Fluphenazine was previously available under the brand name Prolixin. The typical maintenance dose in adults in 12.5 to 25 mg im or sc every 3 to 6 weeks. Common side effects include drowsiness, dizziness, headache, blurred vision, dry mouth, constipation, tremor, restlessness, muscle spasms and weight gain. Rare but potentially severe adverse effects include suicidal thoughts or behaviors, neuroleptic malignant syndrome and tardive dyskinesia.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in up to 40% of patients on long term therapy with phenothiazines, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Several instances of clinically apparent acute liver injury have been reported due to fluphenazine, which have resembled the liver injury caused by chlorpromazine and other phenothiazines. The onset of phenothiazide-related jaundice is usually within 1 to 4 weeks, and the pattern of serum enzyme elevations is typically cholestatic or mixed. Immunoallergic features (fever, rash and eosinophilia) are present in some cases, but they are usually mild and self-limited; autoantibodies are rare. Most importantly, phenothiazide induced jaundice can be prolonged and associated with vanishing bile duct syndrome. All phenothiazine antipsychotic agents are probably capable of causing cholestatic liver injury, but the frequency of hepatotoxicity appears to be far greater with chlorpromazine than with others such as fluphenazine.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which fluphenazine and other phenothiazines cause serum aminotransferase elevations is not known. Many aspects of the clinical presentation of phenothiazine hepatotoxicity (short latency period, fever, eosinophilia) suggest a hypersensitivity reaction, and rechallenge typically causes a rapid recurrence of injury. Fluphenazine is extensively metabolized by the liver via sulfoxidation and oxidation, and some instances of serum aminotransferase elevations as well as more clinically apparent liver injury may be caused by production of a toxic intermediate of its metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on fluphenazine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. The acute cholestatic hepatitis caused by fluphenazine is typically self-limited and benign. While cases of prolonged jaundice and cholestasis have not been described with fluphenazine, many instances of vanishing bile duct syndrome have been attributed to other phenothiazides. Many patients with chronic cholestasis eventually improve but they often have persistent enzyme elevations and biliary cirrhosis. Fatalities from fluphenazine jaundice have not been reported. Rechallenge should be avoided. Patients with fluphenazine induced liver injury may have cross sensitivity to other phenothiazines, but generally tolerate the atypical antipsychotics.

Drug Class: Antipsychotic Agents

Other Drugs in the Subclass, Phenothiazines: Chlorpromazine, Perphenazine, Prochlorperazine, Thioridazine, Trifluoperazine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fluphenazine – Generic, Prolixin®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fluphenazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fluphenazine | 69-23-8 | C22-H26-F3-N3-O-S | Fluphenazine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 February 2018

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs including chlorpromazine published in 1999; several hundred cases of jaundice related to chlorpromazine have been reported, usually cholestatic, arising after 1-5 weeks, often with fever and eosinophilia, sometimes causing vanishing bile duct syndrome; other phenothiazines have only rarely been linked to liver injury, except for prochlorperazine).
Larry D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of phenothiazine induced liver injury; liver enzyme elevations arise in up to 42% of patients treated with phenothiazines, and hundreds of cases of chlorpromazine jaundice have been published, frequency ~0.5-1%; onset in 2-5 weeks, usually with an acute cholestatic hepatitis with jaundice and pruritus; a prodrome of fever and abdominal pain is common; prolonged course in 7% but often benign; other phenothiazines including fluphenazine have been linked to liver injury similar to that of chlorpromazine, but with a lower frequency).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 417-56. (Textbook of pharmacology and therapeutics).
Walters GM, Terrence C, Steckel R. Jaundice following administration of fluphenazine dihydrochloride. Am J Psychiatry 1963; 120: 81-2. (29 year old woman developed rash 2 days after starting fluphenazine, followed by facial edema and then jaundice with a tender liver [bilirubin 4.7 mg/dL, Alk P ~3 times ULN], resolving within 2 weeks of stopping). 13998698
McQueen EG. Toxic effects of phenothiazine tranquillizers. N Z Med J 1963; 62: 460-2. (Review of the phenothiazines and their side effects; “Jaundice has occurred in about 1% of patients taking chlorpromazine, and also, although less frequently, in patients taking one of the more recently developed analogues”). 14073060
Walker CO, Combes B. Biliary cirrhosis induced by chlorpromazine. Gastroenterology 1966; 51: 631-40. ( Two patients, a 32 year old woman and a 31 year old man developed persistent jaundice [>4 years], cholestasis and liver fibrosis 3 and 4 weeks after starting chlorpromazine; acute cholestatic hepatitis evolving into chronic form with biopsies showing cirrhosis and complications of portal hypertension). 5926937
Ishak KG, Irey NS. Hepatic injury associated with the phenothiazines. Clinicopathologic and follow-up study of 36 patients. Arch Pathol 1972; 93: 283-304. (Review of 36 liver biopsies of phenothiazine induced hepatotoxicity from the files of the Armed Forces Institute of Pathology; 33 were due to chlorpromazine, 3 prochlorperazine; mean onset 15 days, eosinophilia in 73%, mean bilirubin 12.4 mg/dL, Alk P ~8 fold elevated, ALT 146 U/L; 6 [17%] had prolonged course for 10-16 months). 5017281
Nolen WA, Börger J. Disturbances of liver function of long acting neuroleptic drugs. Pharmakopsychiatr Neuropsychopharmakol 1978; 11: 199-204. (Analysis of 39 patients receiving fluphenazine; abnormalities of thymol turbidity were common, small number had ALT elevations, but no details given). 674355
Snyder S. Fluphenazine jaundice. Report of a case. Am J Gastroenterol 1980; 73: 336-40. (19 year old woman developed jaundice within days of starting fluphenazine [bilirubin 3.9 mg/dL, AST 2660 U/L, Alk P 181 U/L], improving over the next 2 weeks, but with rise in AST with restarting [59 to 94 U/L], and ultimately falling to normal after stopping; patient had recent history of injection drug use and report predated availability of tests for hepatitis C). 7416129
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (Among 572 cases of drug induced liver disease seen between 1968-78 in Denmark, 51 were attributed to chlorpromazine [9%, ranking 2nd behind halothane], latency averaging 14 days [range 11-46]; 5 deaths; no mention of fluphenazine or other phenothiazines). 6982502
Kennedy P. Liver cross-sensitivity to antipsychotic drugs. Br J Psychiatry 1983; 143: 312. . (26 year old man with schizophrenia developed jaundice while on chlorpromazine [bilirubin 14.7 mg/dL, ALT 240 U/L, Alk P 294 U/L], had enzyme elevations within 2 weeks of starting haloperidol but then tolerated depixol [a thioxanthene antipsychotic not available in the US] long term). 6138114
Jones JK, Van de Carr SW, Zimmerman H, Leroy A. Hepatotoxicity associated with phenothiazines. Psychopharmacol Bull 1983; 19: 24-7. (Analysis of several health databases for rates of hepatotoxicity and prescription drug use suggested that all categories of phenothiazides are associated with liver injury, being more common in persons under the age of 50 and not limited to chlorpromazine). 6131467
Holt RJ. Fluphenazine decanoate-induced cholestatic jaundice and thrombocytopenia. Pharmacotherapy 1984; 4: 227-9. (30 year old man developed abdominal pain and fever ~9 months after starting intermittent fluphenazine [bilirubin 2.5 mg/dL, AST 173 U/L, Alk P 100 U/L, low platelet count], resolving rapidly with stopping fluphenazine; patient later tolerated haloperidol without liver injury). 6483640
Kaplowitz N, Aw TY, Simon FR, Stolz A. Drug-induced hepatotoxicity. Ann Intern Med 1986; 104: 826-39. (Review of drug induced hepatotoxicity including phenothiazine induced jaundice). 3518564
Munyon WH, Salo R, Briones DF. Cytotoxic effects of neuroleptic drugs. Psychopharmacology (Berl) 1987; 91: 182-8. (In vitro assay for cytotoxicity of 8 neuroleptic drugs found that chlorpromazine was more toxic than haloperidol and loxapine, but similar to other phenothiazines including fluphenazine). 2883697
Regal RE, Bili JE, Glazer HM. Phenothiazine-induced cholestatic jaundice. Clinical Pharmacy 1987; 6: 787-94. (Review of phenothiazine induced liver injury; cross sensitivity is rare “but does exist”). 2905941
Lok AS, Ng IO. Prochlorperazine-induced chronic cholestasis. J Hepatol 1988; 6: 369-73. (68 year old man developed jaundice 4 weeks after starting prochlorperazine [peak bilirubin 26 mg/dL, ALT 50-90 U/L, Alk P 120-500 U/L], jaundice and pruritus persisting for more than a year, but then gradual clinical improvement but with persistent enzyme elevations, and biopsy 22 months after onset showed fibrosis and paucity of bile ducts). 3392386
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years experience. NZ Med J 1996; 109: 315-9. (Over 21 year period in New Zealand, there were 943 adverse event reports of liver injury involving 205 drugs; chlorpromazine was in the top 20 drugs implicated accounting for 2.7% of cases; prochlorperazine was the cause of 4 cases, but other phenothiazines were not mentioned). 8816722
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were due to chlorpromazine with relative risk of 613: frequency of 261 per 100,000 person year exposures; no mention of fluphenazine). 17539979
Aruna AS, Murungi JH. Fluphenazine-induced neuroleptic malignant syndrome in a schizophrenic patient. Ann Pharmacother 2005; 39: 1131-5. (21 year old man developed fever, tremors, obtundation and tachycardia 7 days after an injection of fluphenazine while continuing thioridazine, haloperidol, lithium and carbamazepine [bilirubin normal, ALT 116 U/L, AST 410 U/L, CPK 36,696], resolving with intensive medical support; enzyme elevations likely from muscle). 15840734
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to phenothiazines). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to psychotropic agents; one each for quetiapine, nefazodone, fluoxetine and venlafaxine, but none for phenothiazines). 20949552
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to perphenazine). 21788760
Marwick KF, Taylor M, Walker SW. Antipsychotics and abnormal liver function tests: systematic review. Clin Neuropharmacol 2012; 35: 244-53. (Systematic review of the literature found rates of any serum enzyme elevation during antipsychotic therapy to range from 5-78% and "clinically significant' elevations in 0-15%; lists 3 reports of clinically apparent liver injury due to fluphenazine, none of which were fatal [Holt 1984; Snyder 1980; Kennedy 1983]). 22986798
Drugs for psychiatric disorders. Treat Guidel Med Lett 2013; 11 (130): 53-64. (Concise review and recommendations on use of antidepressants and antipsychotic medications including fluphenazine; no discussion of hepatotoxicity). 23715100
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period including one non-fatal but icteric case due to chlorpromazine, but none to fluphenazine). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, one non-fatal, but icteric case [from 2003] was attributed to chlorpromazine but none to fluphenazine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.4%] were attributed to antipsychotic agents, including 3 to quetiapine and 2 olanzapine, but none phenothiazines such as fluphenazine). 25754159
Drugs for psychotic disorders. Med Lett Drugs Ther 2016; 58 (1510): 160-4. (Concise review of medications available in the US for therapy of psychotic disorders; mentions fluphenazine, but does not discuss hepatotoxicity). 27960194

## OTHER REFERENCE LINKS

1. Recent References on Fluphenazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fluphenazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fluphenazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fluphenazine)